# Montelukast

## OVERVIEW

### Introduction

Montelukast is an orally available leukotriene receptor antagonist which is widely used for the prophylaxis and chronic treatment of asthma and has been linked to rare cases of clinically apparent liver injury.

### Background

Montelukast (mon" te loo' kast) is a leukotriene receptor antagonist that binds to the CysLT1 and CysLT2 receptors, thereby interfering with inflammatory pathways that are involved in the pathogenesis of asthma and allergic rhinitis. Montelukast has been shown to reduce symptoms of asthma and allergic rhinitis and prevent acute attacks. Montelukast was approved for use in the United States in 1998 and is widely used with more than 20 million prescriptions being filled yearly. Current indications for montelukast include prophylaxis and chronic treatment of asthma, prevention of exercise induced bronchoconstriction and allergic rhinitis. Montelukast is available in several generic forms and under the commercial name Singulair. The recommended dosage for adults is 10 mg once daily. Lower doses and chewable tablets are recommended for pediatric patients. Common side effects include dyspepsia, abdominal discomfort, asthenia, headache, dizziness, fatigue and fever.

### Hepatotoxicity

In clinical trials, mild elevations in serum aminotransferase levels were found in 1% to 2% of patients taking montelukast chronically, but similar rates are reported in matched placebo recipients. The ALT abnormalities were usually mild, asymptomatic and self limited. Clinically apparent liver injury from montelukast is rare; but more than a dozen cases reported in the literature. In these cases, the latency to onset of injury was highly variable, ranging from a few days to several years. Patients presented with anorexia, nausea, right upper quadrant pain, dark urine, and jaundice. The pattern of enzyme elevation was usually mixed, but both hepatocellular or cholestatic patterns have been reported. Allergic features and autoantibody formation were rare. Eosinophilia was often reported, but this may have been due to the underlying allergic condition rather than the liver injury. The injury usually resolved within 1 to 4 months of stopping the drug.

Likelihood score: B (rare but likely cause of clinically apparent liver injury).

### Mechanism of Liver Injury

The cause of hepatotoxicity from montelukast is not known, but the rare incidence, absence of immunoallergic features and long latency period suggest that it is not due to hypersensitivity but rather to altered metabolism. Montelukast is metabolized by the cytochrome P450 system, predominantly by CYP 2C8 but also by CYP 3A4 and 2C9, but it appears to have few clinically significant drug-drug interactions. Nevertheless, the rare instances of hepatotoxicity attributed to montelukast may be caused by formation of toxic or immunogenic intermediates during its metabolism.

### Outcome and Management

Liver injury from montelukast is self limited and resolves in 1 to 4 months. Rechallenge with montelukast may lead to recurrence and should be avoided. Use of other leukotriene receptor antagonists has been reported to be safe, but should be done with caution.

Drug Class: Antiasthmatic Agents

Other Drugs in the Subclass, Leukotriene Receptor Antagonists: Zafirlukast

## CASE REPORT

### Case 1. Cholestatic hepatitis due to montelukast.

[Modified from: Sass DA, Chopra KB, Wu T. A case of montelukast-induced hepatotoxicity. Am J Gastroenterol 2003; 98: 704-5. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/12650820)]

A 42 year old man with asthma, sinusitis and nasal polyps developed jaundice and pruritus 10 months after starting chronic therapy with montelukast (10 mg daily). He took no other medications except for metered inhalants. He had no history of liver disease, hepatitis risk factors or alcohol abuse. On examination, he was jaundiced but had no fever, rash or enlargement of liver or spleen. Laboratory testing showed a total serum bilirubin of 7.6 mg/dL, but only modest elevations in serum enzymes (ALT ~1.5 times and Alk P 2 times ULN). There was a mild eosinophilia (9%). Despite stopping therapy promptly, he had prolonged jaundice, and a liver biopsy 3 months after drug discontinuation showed mild resolving intrahepatic cholestasis. Symptoms improved slowly and serum enzymes were normal when tested 4 months after drug withdrawal.

#### Key Points

Medication: | Montelukast (10 mg daily)
Pattern: | Cholestatic (R=0.8)
Severity: | 3+ (jaundice and hospitalization)
Latency: | 10 months (to onset of jaundice)
Recovery: | 4 months
Other medications: | Beta adrenergic agonist and steroid metered dose inhalers

#### Comment

Cholestatic jaundice arose after 10 months of montelukast therapy. No other cause of liver disease or jaundice was identified and he improved once montelukast was stopped, while other antiasthma medications (metered inhalants) were continued. The latency to onset was unusual and the clinical presentation was that of bland, canalicular cholestasis similar to what occurs with anabolic steroid use. However, this patient denied use of other medications.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Montelukast – Generic, Singulair®

DRUG CLASS

Antiasthma Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=montelukast)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Montelukast Sodium | 151767-02-1 | C35-H36-Cl-N-O3-S.Na | Montelukast structure

## ANNOTATED BIBLIOGRAPHY

References updated: 04 June 2019

Zimmerman HJ. Respiratory supportive drugs. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, p. 717. (Expert review of hepatotoxicity published in 1999; mentions that theophylline has been incriminated in hepatic injury rarely; no mention of montelukast, zafirlukast or zileuton).
Lewis JH. Nonsteroidal anti-inflammatory drugs and leukotriene receptor antagonists. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013. pp. 389-90. (Expert review of liver injury caused by leukotriene receptor antagonists mentions that premarketing trials found elevations of ALT in 1.6% of montelukast- vs 1.2% of placebo-recipients and that rare instances of clinically apparent liver injury have been published since its approval and wide-scale use).
Barnes PJ. Pulmonary pharmacology. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 727-50. (Textbook of pharmacology and therapeutics).
Chiba M, Xu X, Nishime JA, Balani SK, Lin JH. Hepatic microsomal metabolism of montelukast, a potent leukotriene D4 receptor antagonist, in humans. Drug Metab Dispos 1997; 25: 1022-31. (In vitro assessment of metabolism of montelukast by human microsomes; extensively metabolized by P450 system). 9311616
Reiss TF, Chervinsky P, Dockhorn RJ, Shingo S, Seidenberg B, Edwards TB, for the Montelukast Clinical Research Study Group. Montelukast, a once-daily leukotriene receptor antagonist, in the treatment of chronic asthma: a multicenter, randomized, double-blind trial. Arch Intern Med 1998; 158: 1213-20. (Randomized controlled trial of montelukast [n=408] or placebo [n=273] for 12 weeks found similar rates of adverse events, with abnormal ALT in 2.5% of montelukast and 1.5% of placebo recipients and no hepatitis or discontinuation because of liver abnormalities). 9625400
Edelman JM, Turpin JA, Bronsky EA, Grossman J, Kemp JP, Ghannam AF, et al. Oral montelukast compared with inhaled salmeterol to prevent exercise-induced bronchoconstriction. A randomized, double-blind trial. Exercise Study Group. Ann Intern Med. 2000; 132: 97-104. (191 patients with exercise induced bronchospasm received either montelukast or salmeterol aerosol for 8 weeks: in discussion of safety there was no mention of liver side effects or ALT levels). 10644288
Spector SL; Antileukotriene Working Group. Safety of antileukotriene agents in asthma management. Ann Allergy Asthma Immunol 2001; 86 (6 Suppl 1): 18-23. (Review of side effects of antileukotrienes in premarketing studies, ALT elevations found in 1.4% of subjects on zafirlukast vs 1.1% on placebo; in 2.1% on montelukast vs 2.0% on placebo; and in 4.6% of zileuton recipients treated for a year [>3 times ULN; 3 had hyperbilirubinemia] vs 1.1% of controls). 11426912
Storms W, Michele TM, Knorr B, Noonan G, Shapiro G, Zhang J, Shingo S, Reiss TF. Clinical safety and tolerability of montelukast, a leukotriene receptor antagonist, in controlled clinical trials in patients aged > or = 6 years. Clin Exp Allergy 2001; 31: 77-87. (Pooled analysis of safety of montelukast from 11 clinical trials and 5 extensions in 3386 adults and 336 children [6-14 years] showed no differences in incidence of side effects compared to placebo: ALT elevations occurred in 12.9% of montelukast and 11.5% of placebo adult recipients and 3.0% vs 2.2% in children, but no cases of hepatitis or jaundice were reported). 11167954
Margery J, Dot JM, Bredin C, Bonnichon A, Romand F, Guigay J, Vaylet F, L'Her P. [Montelukast induced cytolytic acute hepatitis] Gastroenterol Clin Biol 2003; 27: 129-30. French. (21 year old woman with severe asthma developed ALT elevations [2.5 to 10 times ULN] without jaundice within 3 days of starting montelukast, normalizing within a few weeks of stopping; role of right heart failure and hypoxemia unclear). 12594381
Romero-Gómez M, Sánchez-Muñoz D, Castilla L, Castro M. [Acute hepatitis due to montelukast] Med Clin (Barc) 2003; 120: 239. Spanish. (55 year old woman developed jaundice 4 months after starting montelukast [bilirubin 6.5 mg/dL, ALT 1695 U/L, Alk P 438 U/L, GGT 166 U/L], resolving within 1 month of stopping). 12605820
Russmann S, Iselin HU, Meier D, Zimmermann A, Simon HU, Caduff P, Reichen J. Acute hepatitis associated with montelukast. J Hepatol. 2003; 38: 694-5. (76 year old man developed acute hepatitis like syndrome after 2 years of therapy with montelukast [bilirubin 17.9 mg/dL, ALT 2450 U/L, Alk P 446 U/L], resolving with stopping; positive lymphocyte stimulation assay). 1271388
Sass DA, Chopra KB, Wu T. A case of montelukast-induced hepatotoxicity. Am J Gastroenterol 2003; 98: 704-5. (42 year old man developed jaundice and pruritus 10 months after starting montelukast [bilirubin 7.6 mg/dL, ALT 1.5 times ULN, Alk P 2 times ULN, 9% eosinophilia], resolving within 4 months of stopping: case 1). 12650820
Goldstein MF, Anoia J, Black M. Montelukast-induced hepatitis. Ann Intern Med. 2004; 140: 586-7. (37 year old woman developed jaundice 3 weeks after starting montelukast [bilirubin 10.6 mg/dL; ALT 174 U/L, Alk P 231 U/L], resolving upon stopping, but persistence of ALT elevations and liver biopsy showing chronic portal inflammation). 15069001
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants done in the US between 1990 and 2002, 137 [0.2%] were done for idiosyncratic drug induced acute liver failure, one case was attributed to zafirlukast, but no other antiasthma medications mentioned). 15390328
van Adelsberg J, Moy J, Wei LX, Tozzi CA, Knorr B, Reiss TF. Safety, tolerability, and exploratory efficacy of montelukast in 6- to 24-month-old patients with asthma. Curr Med Res Opin 2005; 21: 971-9. (Controlled trial of montelukast vs placebo in 256 infants showed no difference in side effects or aminotransferase elevations [or asthma symptoms]; none of the laboratory abnormalities led to discontinuation of therapy). 15969897
Walsky RL, Obach RS, Gaman EA, Gleeson JP, Proctor WR. Selective inhibition of human cytochrome P4502C8 by montelukast. Drug Metab Dispos 2005; 33: 413–8. (In vitro studies suggest that montelukast inhibits CYP2C8 metabolism). 15608135
Ghosh G, Manglik AK, Roy S. Efficacy and safety of montelukast as monotherapy in children with mild persistent asthma. Indian Pediatr 2006; 43: 780-5. (Open trial of montelukast in 50 children from India reported elevated liver tests in 18% without further comment). 17033116
Incecik F, Onlen Y, Sangun O, Akoglu S. Probable montelukast-induced hepatotoxicity in a pediatric patient: case report. Ann Saudi Med 2007; 27: 462-3. (5 year old boy developed Jaundice 2 years after starting montelukast therapy [bilirubin 2.8 mg/dL, ALT 658 U/L, Alk P 445 U/L], resolving within 2 weeks of stopping; mentions that in premarketing studies, 1.2% of 1955 montelukast- vs 2.0% of 1180 placebo-treated subjects had increased ALT levels). 18059126
Actis GC, Bugianesi E, Ottobrelli A, Rizzetto M. Fatal liver failure following food supplements during chronic treatment with montelukast. Dig Liver Dis 2007; 39: 953-5. (45 year old woman developed severe acute hepatitis-like syndrome one week after completing a 7 day course of dietary supplement for obesity and while on long term montelukast for asthma [bilirubin 5.7 rising to 29 mg/dL, ALT 2512 U/L, GGT 31 U/L, eosinophilia], with progressive injury, hepatic failure and death; role of montelukast unclear). 17157086
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, none were attributed to montelukast or other antiasthma medications). 18955056
Harugeri A, Parthasarathi G, Sharma J, D'Souza GA, Ramesh M. Montelukast induced acute hepatocellular liver injury. J Postgrad Med 2009; 55: 141-2. (46 year old man developed jaundice 48 days after starting montelukast for asthma [bilirubin 20.1 mg/dL, ALT 2034 U/L, Alk P 140 U/L] with mild ascites, but ultimate resolution within 2 months of stopping). 19550064
Agarwal VK, McHutchison JG, Hoofnagle JH; Drug-Induced Liver Injury Network. Important elements for the diagnosis of drug-induced liver injury. Clin Gastroenterol Hepatol 2010; 8: 463-70. (Review of the completeness of documentation of drug induced liver disease based upon published case reports of 6 different drugs including 8 of zafirlukast and 4 of montelukast hepatotoxicity, identified important missing data in most reports). 20170750
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury including 1 due to zafirlukast, but none were due to montelukast or zileuton). 20949552
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to montelukast or other antiasthma medications). 23419359
Lebensztejn DM, Bobrus-Chociej A, Kłusek M, Uscinowicz M, Lotowska J, Sobaniec-Lotowska M, Kaczmarski M. Hepatotoxicity caused by montelukast in a paediatric patient. Prz Gastroenterol 2014; 9: 121-3. (3.5 year old boy developed abdominal pain and pruritis 5 months after starting montelukast for asthma [bilirubin 0.8 mg/dL, ALT 1197 U/L, Alk P 305 U/L, GGT 78 U/L], laboratory abnormalities resolving within 3 months of stopping). 25061494
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, montelukast was implicated in 4 cases, 1 woman and 3 men, ages 44 to 81, latency weeks to 4 months, hepatocellular injury in 3, cholestatic in 1, none fatal but 2 were severe and one resulted in chronic injury). 25754159
Leung JS, Johnson DW, Sperou AJ, Crotts J, Saude E, Hartling L, Stang A. A systematic review of adverse drug events associated with administration of common asthma medications in children. PLoS One 2017; 12: e0182738. (Systematic review of adverse events in reported in 46 clinical studies of commonly used asthma medications including 25 events associated with leukotriene antagonists affecting 9 organ systems; hepatotoxicity not mentioned). 28793336
Drugs for asthma. Med Lett Drugs Ther 2017; 59 (1528): 139-46. (Concise review of medications used for asthma including the leukotriene modifiers; mentions that zafirlukast and zileuton have been reported to cause life-threatening hepatic injury and that monitoring of liver tests during therapy is recommended). 28880849
Haarman MG, van Hunsel F, de Vries TW. Adverse drug reactions of montelukast in children and adults. Pharmacol Res Perspect 2017; 5: e00341. (Review of adverse drug reactions to montelukast reported to two large pharmacovigilance databases [Netherlands and WHO] found depression, headache, aggressive behavior, suicidal ideation, insomnia and anxiety to be the most frequently described events and special focus was on the more than 500 cases of allergic granulomatous angiitis; no mention of hepatic adverse events except for a hospitalization for "abnormal liver function test"). 28971612
Kim MK, Lee SY, Park HS, Yoon HJ, Kim SH, Cho YJ, Yoo KH, et al. A randomized, multicenter, double-blind, phase III study to evaluate the efficacy on allergic rhinitis and safety of a combination therapy of montelukast and levocetirizine in patients with asthma and allergic rhinitis. Clin Ther 2018; 40: 1096-107. (Among 228 adults with allergic rhinitis and mild-to-moderate asthma treated with montelulast with or without levocetirizine for 4 weeks, adverse reactions were not common and were generally mild, there were no hepatic serious adverse events and no mention of ALT elevations). 29945738

## OTHER REFERENCE LINKS

1. Recent References on Montelukast: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Montelukast/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Montelukast: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Montelukast)